# Sulfonylureas

## OVERVIEW

The sulfonylureas are a class of agents that lower blood sugar as a result of increasing release of insulin from the pancreas. The sulfonylureas are used for the therapy of mild-to-moderate type 2 diabetes in conjunction with diet, and can be used alone or in combination with metformin, thiazolidinediones or other hypoglycemic agents. The sulfonylureas have been associated with rare cases of idiosyncratic drug induced liver disease with somewhat similar pattern of onset, injury and outcome.

While the sulfonylureas are derivatives of sulfonamides, they have no intrinsic antibacterial activity. They are believed to lower blood glucose levels by stimulating insulin release from pancreatic beta cells. However, their effects on blood glucose with chronic therapy are more complex, and the sulfonylureas may have extra-pancreatic actions that affect blood sugar, reducing hepatic clearance of insulin or increasing insulin sensitivity. The sulfonylureas have little effect in type 1 diabetes, in which there is a deficiency in insulin producing pancreatic beta cells. The sulfonylureas are widely used and are generally considered a first line of medication therapy for type 2 diabetes.

The sulfonylureas are divided into first and second generation agents, based upon their relative potency. All sulfonylureas share a similar structure, being substituted arylsulfonylureas. They differ on the basis of substitutions at the para positions at the two ends of the arylsulfonylurea molecule. The first generation sulfonylureas include chlorpropamide, tolazamide and tolbutamide. These agents are now rarely used although still available in the United States. The second generation sulfonylureas include gliclazide, glimepiride, glipizide and glyburide (known as glibenclamide outside of the United States) which are active in lower concentrations, are effective when taken once daily and have fewer of the troublesome dose related side effects of the first generation sulfonylureas, such as headache, nausea, anorexia, fatigue and paresthesias. The sulfonylureas (particularly the first generation agents) can also cause alcohol intolerance (flushing) through inhibition of alcohol dehydrogenase. The sulfonylureas are all labelled with a warning of increased risk of cardiovascular mortality with long term use.

For discussion of their current use, chemical structure and hepatotoxicity, the sulfonylureas are discussed individually in the sections on first or second generation agents. References and case examples are given below in this Overview section.

Drug Class: Antidiabetic Agents

Drugs in the Subclass Sulfonylureas: First Generation Sulfonylureas, Second Generation Sulfonylureas

## CASE REPORTS

### Case 1. Immunoallergic cholestatic hepatitis due chlorpropamide with cross sensitivity to tolbutamide, but not glyburide.

[Modified from: Rumboldt Z, Bota B. Favorable effects of glibenclamide in a patient exhibiting idiosyncratic hepatotoxic reactions to both chlorpropamide and tolbutamide. Acta Diabetol Lat 1984; 21: 387-91. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/6442088)]

A 42 year old woman developed rash, fever, abdominal pain and jaundice 4 weeks after starting chlorpropamide and a few days after receiving ampicillin. She was anicteric but had low grade fevers and a pruritic maculopapular rash over the chest, arms and legs. Ampicillin was stopped and corticosteroids started while the chlorpropamide was continued. The fever improved and rash began to fade, but she then redeveloped high fevers and became jaundiced with worsening alkaline phosphatase elevations and eosinophilia (Table). Ultrasonography showed no biliary abnormalities. Insulin was substituted for chlorpropamide, and antibiotics were started. Both her fever and abnormal liver tests resolved. A challenge dose of chlorpropamide was given and she promptly developed rash, fever and abdominal pain (with only mild increases in liver test results). She was switched to tolbutamide (100 mg daily) and did well until 4 weeks later when she redeveloped fever and jaundice. Tolbutamide was stopped and she improved while maintained on insulin. Two months later glyburide (glibenclamide) was started. Over the next four months she remained well without fever or laboratory test abnormalities.

#### Key Points

Medication: | Chlorpropamide (Diabinese: 500 mg daily)
Pattern: | Cholestatic (R=<1.0)
Severity: | 3+ (hospitalization for jaundice)
Latency: | 4 weeks
Recovery: | Delayed by rechallenge
Other medications: | Ampicillin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
4 weeks | 0 | 178 | 50 | 1.6 | Ampicillin stopped
5 weeks | 0 | 177 | 313 | 5.7 | Chlorpropamide stopped
5 weeks | 0 | 280 | 453 | 4.8
6 weeks | 1 week | 241 | | 4.4
7 weeks | 2 weeks | 70 | | 1.9
8 weeks | 3 weeks | 58 | 61 | 2.6
9 weeks | 4 weeks | 49 | 158 | 1.9 | Chlorpropamide challenge
10 weeks | 5 weeks | 22 | 63 | 1.2 | Tolbutamide started
12[2] weeks | 7 weeks | 22 | 24 | 1.0
15[5] weeks | 10[0] weeks | 93 | 72 | 1.7 | Tolbutamide stopped
26[16] weeks | 21[11] weeks | 19 | 22 | 0.9 | Glyburide started
30[20] weeks | 25[15] weeks | 18 | 21 | 0.8
40[30] weeks | 35[25] weeks | 19 | 62 | 0.6
44[34] weeks | 39[29] weeks | 16 | 28 | 0.7
Normal Values | | <25 | <30 | <1.2

* Converted from μmol: 1 mg/dL=17.1 μmol. Times in brackets refer to weeks after starting or stopping tolbutamide.

#### Comment

The patient developed signs of hypersensitivity (fever, rash, eosinophilia) and mild cholestatic liver injury after 4 weeks of chlorpropamide therapy. The rash and fever were initially attributed to ampicillin, but fevers returned and frank jaundice appeared while chlorpropamide was continued. She improved once chlorpropamide was stopped (also while receiving corticosteroids) and had an immediate recurrence upon rechallenge (fever, rash and abdominal pain), providing convincing evidence for the role of chlorpropamide in the immunoallergic hepatitis. Interestingly, there was a recurrence with a similar pattern of onset (~4 weeks) and injury with tolbutamide (another first generation sulfonylurea), but not with glyburide (called glibenclamide in Europe; a second generation sulfonylurea). The liver injury associated with first generation sulfonylureas varies greatly in clinical presentation, but typically arises after 2 to 8 weeks of therapy, is predominantly cholestatic, mild-to-moderate in severity, and associated with features of hypersensitivity in up to half of cases.

### Case 2. Acute hepatitis due to gliclazide.

[Modified from: Chitturi S, Le V, Kench J, Loh C, George J. Gliclazide-induced acute hepatitis with hypersensitivity features. Dig Dis Sci 2002; 47: 1107-10. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/12018908)]

A 42 year old woman developed rash and pruritus 4 weeks after starting metformin and gliclazide for newly diagnosed type 2 diabetes. She was treated with antihistamines and topical agents and improved, but two weeks later routine testing revealed marked elevations in liver tests. She had no history of drug reactions, alcohol abuse or risk factors for viral hepatitis. At the time of her initial diagnosis of diabetes and before starting medications, her liver enzymes were mildly elevated (ALT 61 U/L, AST 95 U/L, alkaline phosphatase 78 U/L), but she had no symptoms of liver disease and had no history of jaundice or other significant medical illnesses. Her only other medications were oral contraceptives that she had been using for 3 years. Six weeks after starting antidiabetic medications, laboratory tests showed a total bilirubin of 2.9 mg/dL, ALT 1605 U/L, alkaline phosphatase 158 U/L and eosinophils 18% (absolute count 1390/μL). Physical examination was unrevealing; her skin rash had resolved. Metformin was thought to be the cause of the liver injury and was stopped. Over the next few days, however, she became noticeably jaundiced and bilirubin levels rose (Table). Gliclazide was stopped. When her prothrombin time was found to be abnormal (21 seconds), she was admitted for observation. Tests for hepatitis A, B and C (including HCV RNA) were negative as were autoantibodies, although serum immunoglobulin levels were mildly elevated (IgG 2310 mg/dL, total serum globulins 4.6 g/dL). A liver biopsy showed fibrosis and regenerative nodules consistent with cirrhosis along with focal necrosis, moderate inflammation, Mallory's hyaline and prominent ballooning degeneration, suggestive of an underlying nonacloholic steatohepatitis with a superimmposed acute drug induced liver injury. Once glicazide was stopped, liver tests began to improve and were normal within a few weeks. Metformin was then reintroduced and serum enzymes remained normal.

#### Key Points

Medication: | Gliclazide (80 mg twice daily)
Pattern: | Hepatocellular (R=29)
Severity: | 4+ (jaundice and prolongation of prothrombin time)
Latency: | 6 weeks
Recovery: | 1 month
Other medications: | Metformin, fexofenadine (for rash), oral contraceptives

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
Pre | 0 | 61 | 78 | Normal | Diagnosis
4 weeks | 0 | Rash and pruritus
6 weeks | 0 | 1605 | 158 | 2.9 | Metformin stopped
| 3 days | 2598 | | 4.7 | Gliclazide stopped
7 weeks | 7 days | 2300 | | 7.8 | Protime 21 sec
| 10 days | 2200 | | 8.4 | Liver biopsy
8 weeks | 2 weeks | 450 | | 3.0
10 weeks | 4 weeks | 40 | | 2.2
11 weeks | 5 weeks | 25 | | 1.1
13 weeks | 7 weeks | 25 | | 1.0 | Metformin restarted
14 weeks | 8 weeks | 25 | | 0.8
16 weeks | 10 weeks | 25 | | 0.7
24 weeks | 18 weeks | 25 | | 0.6
Normal Values | | <40 | <115 | <1.2

* Some values and times estimated from Figure 4.

#### Comment

This patient with type 2 diabetes appeared to have preexisting nonalcoholic steatohepatitis. At the time of the initial diagnosis of diabetes, her serum aminotransferase levels were elevated and a liver biopsy taken at the height of the acute injury demonstrated fibrosis and regenerative nodules indicative of an incomplete cirrhosis, while the prominent ballooning degeneration and Mallory's hyaline suggested the cause to be steatohepatitis. The timing of onset of jaundice, 6 weeks after starting gliclazide, the mild immunoallergic features (rash, eosinophilia), and rapid improvement after discontinuation are highly suggestive of sulfonylurea induced acute liver injury. Metformin was initially thought to be the cause, but stopping it did not result in rapid improvement and she later tolerated reintroduction without a rise in serum enzymes. Indeed, metformin has been used as therapy of nonalcoholic steatohepatitis, although its effects may be largely the result of weight loss, which is typical of metformin. Patients with nonalcoholic steatohepatitis are often considered to be at a higher risk for drug induced liver injury, but they probably are just more likely to have a more severe course if the idiosyncratic injury arises. This patient should be warned against the use of other sulfonylureas. Whether she is at higher risk of hypersensitivity reactions to other sulfa containing drugs (sulfonamides, celecoxib) is unknown.

## ANNOTATED BIBLIOGRAPHY

References updated: 16 March 2018

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 575-79. (Expert review of sulfonylureas and liver injury published in 1999 which are described as having a low rate of hepatic complications with variable presentation).
De Marzio DH, Navarro VJ. Sulfonylureas. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 529. (Review of hepatotoxicity of drugs for diabetes including first and second generation sulfonylureas).
Powers AC, D'Alessio D. Therapy of diabetes. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1248-67. (Textbook of pharmacology and therapeutics).
Brown G, Zoidis J, Spring M. Hepatic damage during chlorpropamide therapy. JAMA 1959; 170: 2085. Not in Pub Med (Three women, ages 50, 67 and 57 years, with onset of liver injury after 3-6 weeks of chlorpropamide therapy, two with jaundice [bilirubin 0.2-8.9 mg/dL, Alk P 2-7 times ULN, ALT not available], resolving in all three within 2-5 weeks of stopping; one patient had fever, rash and eosinophilia).
Hadley WB, Kachadurian A, Marble A. Studies with chlorpropamide in diabetic patients. Ann NY Acad Sci 1959; 74: 621-4. (Analysis of 72 patients given chlorpropamide; one developed jaundice after 3 weeks [bilirubin 3.9 mg/dL, ALT not done, Alk P 4 times ULN, eosinophils 10%], biopsy showed intrahepatic cholestasis, resolving within 2 months of stopping). 13637600
Hamff IH, Ferris AH, Evans EC, Whiteman HW. The effect of tolbutamide and chlorpropamide on patients exhibiting jaundice as a result of previous chlorpropamide therapy. Ann NY Acad Sci 1959; 74: 820-9. (Three case reports of jaundice arising 2-4 weeks after starting chlorpropamide [bilirubin 1.9-10.7 mg/dL, Alk P 2-7 times ULN, ALT not available], resolving within 4-8 weeks of stopping, and no recurrence on starting tolbutamide or restarting chlorpropamide at lower doses). 13637623
Reichel J, Goldberg SB, Ellenberg M, Schaffner F. Intrahepatic cholestasis following administration of chlorpropamide. Report of a case with electron microscopic observations. Am J Med 1960; 28: 654-60. (67 year old woman developed jaundice and itching 8 weeks after starting chlorpropamide [bilirubin 30 mg/dL, AST 91 U/L, Alk P 26.2 KA U/L], biopsy showed intrahepatic cholestasis, resolving within 2 months of stopping; weakly positive rechallenge to chlorpropamide, not to tolbutamide). 14437049
Baird RW, Hull JG. Cholestatic jaundice from tolbutamide. Ann Intern Med 1960; 53: 194. (57 year old man developed jaundice after intermittent use of tolbutamide for 8 weeks [bilirubin 7.7 mg/dL, AST 260 U/L, Alk P 2 times ULN], underwent emergency laparotomy, but ultimately recovered). 13795916
McMahon TF. Cholestatic jaundice, liver decompensation, and shock resulting from tolbutamide: report of a case. Med Ann DC 1963; 509. (50 year old man developed jaundice and ascites after being on tolbutamide for 3 years; whiskey bottles found in his room; no information on liver enzymes or histology). 14086226
Stocchi F, Mastrilli B. [Contribution to the study of jaundice caused by intrahepatic cholestasis of drug origin: forms of chlorpropamide and sulfamethoxypyridazine.] Clin Ter 1962; 22: 925-32. Italian. (75 year old man developed jaundice 10 days after starting chlorpropamide [bilirubin 14.2 mg/dL, ALT 30 U/L, Alk P 2.5 times ULN], resolving within 2 months of stopping). 13917277
Arteaga A, Valdicieso V, Etchart M. [Hepatic function in patients treated with Chlorpropamide for prolonged periods.] Rev Med Chil 1964; 92: 450-5. Spanish. 14208075
Ciammaichella A, Cantera N. [Contribution to the study of the toxic effects due to hypoglycemic sulfonylureas.] Minerva Med 1964; 55: 657-64. Italian. (Review of literature and three case reports: Case 1 was a 58 year old woman who developed fever and rash 3 weeks after starting chlorpropamide, followed by jaundice [bilirubin 10.7 mg/dL, Alk P 6 times ULN], resolving rapidly and not recurring when restarted at lower dose; Case 2 was a 68 year old woman who developed symptoms, rash and fever 2 weeks after starting chlorpropamide [bilirubin 6.4 mg/dL, Alk P 2 times ULN], resolving rapidly and not recurring when restarted at lower dose; Case 3 was a 50 year old woman who developed symptoms within 3 days of starting chlorpropamide with eosinophilia, later tolerating tolbutamide, but redeveloping symptoms on restarting chlorpropamide). 14140236
Ciammaichella A, Cantera N. [Jaundice during oral antidiabetic therapy.] Fegato 1963; 18: 444-56. Italian. (Similar review and description of 3 cases of sulfonylurea hepatotoxicity as in Ciammaichella [1964]). 14117143
Haunz EA, Cornatzer WE, Luper M, Forks G. Liver function in Chlorpropamide therapy. Five year clinical study of 181 patients. JAMA 1964; 188: 237-40. (Summary of routine liver tests done on 181 patients treated with chlorpropamide for 1 week to 5 years, 125-750 mg/day, ~5% had minor, transient AST elevations (<2 times ULN), ~7% had mild, transient Alk P elevations). 14113990
Ostman J, Groenberg A. [Side-effects in the oral treatment of diabetes with sulfonylureas.] Nord Med 1964; 72: 1388-95. Swedish. (Review and summary of published literature on side effects of sulfonylureas). 14210083
Collens WS, Dobkin GB. Cholestatic jaundice following use of sulfonylurea drugs. N Y State J Med 1965; 65: 907-9. (21 year old man developed nausea after 1 week and jaundice after 3 weeks of chlorpropamide therapy, with rapid resolution upon stopping; starting tolbutamide led to recurrence 5 weeks later [bilirubin 4.5 mg/dL, ALT 210 U/L, Alk P 2.5 times ULN], resolving within a few months). 14265335
Ferrero E, Marioni G, Antognetti R, Falchi F. [Tolazamide and hepatic damage] Minerva Med 1965; 56: 3609-13. Italian. 5841666
Goldstein MJ, Rothenberg AJ. Jaundice in a patient receiving acetohexamide. N Engl J Med 1966; 275: 97-9. (58 year old man developed jaundice 3 weeks after starting acetohexamide [bilirubin 20.7 mg/dL, ALT 630 U/L, Alk P 4 times ULN]; biopsy showed cirrhosis, no recurrence with restarting acetohexamide). 5936873
Grottum KA. [Liver damage due to phenylbutazone and chlorpropamide] Tidsskr Nor Laegeforen 1966; 86: 1096-8. Norwegian. 5919203
Balodimos MC, Camerini-Dávalos RA, Marble A. Nine years. experience with tolbutamide in the treatment of diabetes. Metabolism 1966; 15: 957-70. (Experience in using tolbutamide in 3644 diabetic patients at Joslin Clinic over 9 years; 4 cases of untoward liver events, possibly due to tolbutamide; one case of jaundice after 3 months with progressive liver failure and death). 5950894
Henderson BE, Field RA. Evaluation of hepatic function during long-term Chlorpropamide therapy. Pa Med 1967; 70: 61-2. (Testing of 20 patients on long term [>3 years] therapy with chlorpropamide [500 mg/day] found normal levels of AST in all, normal Alk P in 90% and normal BSP retention in 80%; "..granted the number of patients evaluated was small.."). 6065567
Gregory DH, Zaki GF, Sarosi GA, Carey JB Jr. Chronic cholestasis following prolonged tolbutamide administration. Arch Pathol 1967; 84: 194. (Not in PubMed) (48 year old woman developed jaundice 12 months after starting tolbutamide, which was continued for another 12 months when she was found to have bilirubin 20.5 mg/dL, ALT 103 U/L, Alk P 64 KA/L, dying shortly thereafter of hepatic failure; autopsy showed ductopenia, severe cholestasis, but scant necrosis; no mention of AMA testing).
Rotolo V. [Jaundice in diabetics treated with sulfonylureas. On a clinical case of jaundice caused by tolazamide] Friuli Med 1968; 23: 257-75. Italian. (Review of hepatotoxicity of sulfonylureas and case of jaundice arising after 3 months of tolazamide therapy [bilirubin 8.0 rising to 18 mg/dL, ALT 200 U/L, Alk P ~2 times ULN], biopsy showing acute injury; repeat, follow up biopsy showing recovery). 5747401
Ananth JV, Ban TA, Lehmann HE. Tolbutamide jaundice associated with multiple drug therapy. Can Med Assoc J 1970; 103: 1194. (Complex case of itching and jaundice arising after uncertain duration [?4 years] of tolbutamide therapy and brief use of thioridazine [bilirubin 5.5 mg/dL, AST 13.8 and Alk P 10.4 unknown units], with rechallenge jaundice was said to return, but bilirubin was 1.1 mg/dL). 5489326
de Baere H, Decraene P, de Leeuw I, Lemmens P, Verhaegen H. [Hypoglycemia caused by oral antidiabetic agents] Ned Tijdschr Geneeskd 1973; 117: 1021-4. Dutch. 4206176
Van Thiel DH, De Belle R, Mellow M, Widerlite L, Philipps E. Tolazamide hepatotoxicity. A case report. Gastroenterology 1974; 67: 506-10. (62 year old man developed jaundice 4 weeks after starting tolazamide that was continued for another month [bilirubin rising from 8.9 to 16.5 mg/dL, AST 50 U/L, Alk P 180 U/L], resolving within 2 months of stopping). 4855219
Clarke BF, Campbell IW, Ewing DJ, Beveridge GW, MacDonald MK. Generalized hypersensitivity reaction and visceral arteritis with fatal outcome during glibenclamide therapy. Diabetes 1974; 23: 739-42. (67 year old man developed fever, rash and jaundice 4 weeks after starting glyburide [peak bilirubin 12.2 mg/dL, ALT 152 U/L, Alk P 125 KA units/L]; biopsy showed cirrhosis; patient developed progressive renal failure and died, possibly had underlying chronic hepatitis C). 4213123
Rigberg LA, Robinson MJ, Espiritu CR. Chlorpropamide-induced granulomas. A probable hypersensitivity reaction in liver and bone marrow. JAMA 1976; 235: 409-10. (62 year old woman developed rash, fever and eosinophilia 2 weeks after starting chlorpropamide [bilirubin 0.8 mg/dL, AST 135 U/L, Alk P 405 U/L], liver and bone marrow biopsies showed granulomas; repeat biopsies in follow up were normal). 128640
Frier BM, Stewart WK. Cholestatic jaundice following chlorpropamide self-poisoning. Clin Toxicol 1977; 11: 13-7. (19 year old woman took an overdose of chlorpropamide and required 6 days of iv glucose; developing nausea at 14 and jaundice at 21 days [bilirubin 6.6 mg/dL, Alk P ~2 times ULN, AST 124 U/L, GGT 50 U/L], resolving over subsequent 4 weeks). 872537
LoIudice TA, Lang JA. Tolazamide-induced hepatic dysfunction. Am J Gastroenterol 1978; 69: 81-3. (33 year old man developed abnormal liver tests on tolazamide, latency unclear [bilirubin 1.4 mg/dL, AST 150 U/L, Alk P 1392 U/L], biopsy showed inflammation without cholestasis or necrosis; positive rechallenge). 645691
Ingelmo M, Vivancos J, Bruguera M, Sierra J, Balcells A. [Hypersensitivity vasculitis and granulomatous hepatitis induced by glybenclamide: a case report]. Med Clin (Barcelona) 1980; 75: 306-8. (51 year old man developed fever, rash, fatigue and eosinophilia arising after uncertain period of glibenclamide therapy [bilirubin 0.6 mg/dL, AST 57 U/L, Alk P 4 times ULN, GGT 355 U/L], granulomas on liver biopsy, resolved when glibencamide was stopped; follow up liver biopsy normal). 6776355
Bridges ME, Pittman FE. Tolazamide-induced cholestasis. South Med J 1980; 73: 1072-4. (54 year old woman developed jaundice 15 months after starting chlorpropamide [bilirubin 14 mg/dL; ALT 225 U/L, Alk P 180 U/L], rapid recovery upon withdrawal, but rapid recurrence upon starting tolazamide [bilirubin 21 mg/dL, ALT 26 U/L, Alk P 306 U/L] and slow recovery). 7403921
Gill MJ, Ratliff DA, Harding LK. Hypoglycemic coma, jaundice, and pure RBC aplasia following Chlorpropamide therapy. Arch Intern Med 1980; 140: 714-5. (41 year old woman developed hypoglycemia, anemia and mild cholestatic liver injury 4 weeks after starting chlorpropamide [bilirubin 2.2 mg/dL, Alk P 890 U/L, AST 316 U/L], resolving within 6 weeks of stopping). 7396601
Wongpaitoon V, Russell RF, Mills PR, Patrick RS. Intrahepatic cholestasis and cutaneous bullae associated with glibenclamide therapy. Postgrad Med J 1981; 57: 244. (61 year old man developed severe hypoglycemia 5 months after starting glyburide with concurrent rash [bullae] and cholestatic hepatitis [bilirubin 3.2 mg/dL, ALT 146 U/L, Alk P 2420 U/L], resolving rapidly within a month of stopping). 6794018
Bell RL. Chlorpropamide hepatitis. Ala Med 1984; 53: 20, 22-3. (Two cases and literature review; jaundice arose after 4 and 3 weeks of chlorpropamide therapy [bilirubin 12.5 and 4.9 mg/dL, AST 670 and 200 U/L, Alk P 349 and 161 U/L], resolving within 1-2 months of stopping, biopsy showing cholestatic hepatitis). 6731219
Schneider HL, Hornbach KD, Kniaz JL, Efrusy ME. Chlorpropamide hepatotoxicity: report of a case and review of the literature. Am J Gastroenterol 1984; 79: 721-4. (52 year old woman developed rash followed by jaundice beginning 2 weeks after starting chlorpropamide [bilirubin 0.8 rising to 2.6 mg/dL, ALT 456 U/L, Alk P 130 rising to 858 U/L]; review of literature indicating latency of 2-5 weeks, cholestatic enzyme pattern and eosinophila in 50% of cases). 6475904
Rumboldt Z, Bota B. Favorable effects of glibenclamide in a patient exhibiting idiosyncratic hepatotoxic reactions to both chlorpropamide and tolbutamide. Acta Diabetol Latina 1984; 2: 387. (42 year old woman developed rash, fever and jaundice 4 weeks after starting chlorpropamide and after a few days of ampicillin [bilirubin 1.6 rising to 4.4 mg/dL, AST 178 U/L, Alk P 1.7 rising to 15 times ULN, GGT 202, eosinophils 20%], finally resolving with stopping chlorpropamide; with immediate positive rechallenge to chlorpropamide, delayed recurrence to tolbutamide, but not glyburide: Case 1). 6442088
Baciewicz AM, Dattilo R, Willis SE, Kershaw JL. Jaundice and rash associated with chlorpropamide. Diabetes Care 1985; 8: 200-1. (42 year old woman developed jaundice 4 weeks after starting chlorpropamide [bilirubin 8.6 mg/dL, AST 165 U/L, GGT 625 U/L], resolving rapidly upon stopping). 3158501
Gupta R, Sachar DB. Chlorpropamide-induced cholestatic jaundice and pseudomembranous colitis. Am J Gastroenterol 1985; 80: 381-3. (59 year old man developed jaundice 4 weeks after starting chlorpropamide [bilirubin 7.0 mg/dL, ALT 332 U/L, Alk P 542 U/L], course complicated by pseudomembranous colitis). 2859803
Nakao NL, Gelb AM, Stenger RJ, Siegel JH. A case of chronic liver disease due to tolazamide. Gastroenterology 1985; 89: 192-5. (81 year old woman tolerated chlorpropamide for 2 years, but developed cholestatic liver injury 3 weeks after being switched to tolazamide [bilirubin 22 mg/dL, ALT 63 U/L, Alk P 362 U/L]; slow recovery and persistence of abnormal ALT [79 U/L] and Alk P [258 U/L] with liver biopsy showing portal inflammation and duct injury and possibly loss). 4007403
Clementsen P, Hansen CL, Høegholm A. [Glipizide induced toxic hepatitis] Ugeskr Laeger 1986; 148: 771-2. Danish. (72 year old woman developed jaundice 3.5 months after starting glipizide [bilirubin 17.2 mg/dL, ALT 1288 U/L, Alk P 367 U/L], with subsequent worsening and death 14 days later despite stopping glipizide]. 3705214
Goodman RC, Dean PJ, Radparvar A, Kitabchi AE. Glyburide-induced hepatitis. Ann Intern Med 1987; 106: 837-9. (Two women, ages 61 and 63 years, developed jaundice 1 and 4 weeks after starting glyburide [bilirubin 14.5 and 4.1 mg/dL, AST 60 and 17 times ULN, Alk P 1.7 and 3 times ULN], resolving within few months of stopping). 3107448
Geubel AP, Nakad A, Rahier J, Dive C. Prolonged cholestasis and disappearance of interlobular bile ducts following chlorpropamide and erythromycin ethylsuccinate. Case of drug interaction? Liver 1988; 8: 350-3. (52 year old man developed fever, rash, eosinophilia and jaundice [bilirubin 8.0 mg/dL, ALT 159 U/L, Alk P 1156 U/L] followed by vanishing bile duct syndrome, cirrhosis and death within 2 years of onset after 3 weeks of erythromycin ethylsuccinate, but also 4 months of chlorpropamide; issue of whether one or both agents was responsible). 3265170
Rank JM, Olson RC. Reversible cholestatic hepatitis caused by acetohexamide. Gastroenterology 1989; 96: 1607-8. (75 year old woman developed jaundice 17 months after starting acetohexamide, but shorting after an increase in dose [bilirubin 7.0 mg/dL, AST 149 U/L, Alk P 567 U/L], resolving rapidly upon stopping). 2714585
Meadow P, Tullio CJ. Glyburide-induced hepatitis. Clin Pharm 1989; 8: 470. (54 year old man found to have asymptomatic rise in Alk P [66 to 220 U/L] and ALT [33 to 151 U/L] one week after raising chronic glyburide dose from 5 to 20 mg daily; rapid resolution on stopping glyburide). 2502355
van Basten JP, van Hoek B, Zeijen R, Stockbrügger R. Glyburide-induced cholestatic hepatitis and liver failure. Case-report and review of the literature. Neth J Med 1992; 40: 305-7. (69 year old woman developed jaundice 10 weeks after starting glyburide [bilirubin 6.9 mg/dL, ALT 405 U/L, Alk P 610 U/L], subsequently progressing to hepatic failure and death, possibly due to delayed stopping of drug). 1436270
Pérez-Roldán F, Aguirre A, Bañares R, Casado M, González-Asanza C, Alvarez E, Clemente G. [Cholestatic hepatitis caused by glybenclamide in a patient with hepatitis C virus]. Rev Esp Enf Digest 1995; 87: 174-6. (68 year old man with chronic hepatitis C developed jaundice 10 weeks after starting glyburide [bilirubin 26.4 mg/dL, ALT 920 U/L, Alk P 651 U/L], resolving upon stopping). 7748712
Krivoy N, Zaher A, Yaacov B, Alroy G. Fatal toxic intrahepatic cholestasis secondary to glibenclamide. Diabetes Care 1996; 19: 385-6. (69 year old woman developed severe cholestatic hepatitis after 7 years of glyburide therapy, but 2 weeks after dose increase [15/mg/day] [bilirubin 5.0 rising to 49 mg/dL, peak ALT 87 U/L, Alk P 583 U/L], subsequently developing progressive hepatic failure and death). 8729168
Kaminski CA, Angueira E. Chlorpropamide-induced cholestatic liver failure resulting in death. Endocr Pract 1996; 2: 191-2. (81 year old man developed nausea and jaundice 4 weeks after starting chlorpropamide [bilirubin 15.2 mg/dL, ALT 255 U/L, Alk P 902 U/L], with subsequent multiorgan failure and death). 15251538
Saw D, Pitman E, Maung M, Savasatit P, Wasserman D, Yeung CK. Granulomatous hepatitis associated with glyburide. Dig Dis Sci 1996; 41: 322-5. (46 year old woman was found to have granulomas on liver biopsy done during a cholecystectomy, having been on glyburide for 3 years [bilirubin 1.4 mg/dL, ALT 41 U/L, Alk P 179 U/L]; minor elevations in Alk P persisted after withdrawal and possibly represented nodular regenerative hyperplasia). 8601376
Petrogiannopoulos C, Zacharof A. Glibenclamide and liver disease. Diabetes Care 1997; 20: 1215. (64 year old man developed jaundice and pruritus 2 months after starting glyburide [bilirubin 10.0 mg/dL, ALT 310 U/L, Alk P 150 U/L], with resolution on stopping). 9203475
Tholakanahalli VN, Potti A, Heyworth MF. Glibenclamide-induced cholestasis. West J Med 1998; 168: 274-7. (64 year old man developed jaundice after 4 years of glyburide therapy [peak bilirubin 19.8 mg/dL, Alk P 263 U/L, ALT 109 U/L], resolving within 3 months of stopping). 9584675
Crespo Valadés E, Ortega Gómez A, Alvarado Izquierdo MI, Magro Ledesma D. [Hepatotoxic reaction associated with metformin and chlorpropamide treatment] Rev Clin Esp 1999; 199: 118-9. Spanish. (68 year old woman developed an acute immunoallergic reaction 2 days after starting metformin with fever, eosinophilia, rash and lymphadenopathy accompanied by a mild cholestatic hepatitis [bilirubin 2.2 mg/dL, ALT 327 U/L, Alk P 2553 U/L], with rapid resolution on stopping therapy; patient was also on long term chlorpropamide). 10216414
Dusoleil A, Condat B, Sobesky R, Pelletier G, Buffet C. [Glimepiride-induced acute hepatitis] Gastroenterol Clin Biol 1999; 23: 1096-7. French. (61 year old woman developed dizziness and weakness 3 months after starting glimepiride [bilirubin 2.0 mg/dL, ALT 27 times ULN, Alk P normal], resolving 6 weeks after stopping). 10592884
Dourakis SP, Tzemanakis E, Sinani C, Kafiri G, Hadziyannis SJ. Gliclazide-induced acute hepatitis. Eur J Gatroenterol Hepatol 2000; 12: 119-121. (60 year old woman developed acute hepatitis 5 weeks after starting gliclazide [bilirubin 3.9 mg/dL, ALT 636 U/L, Alk P 365 U/L, GGT 947 U/L], tests returning to normal within 6 weeks despite switching to glibenclamide [glyburide]). 10656221
Sitruk V, Mohib S, Grando-Lemaire V, Ziol M, Trinchet JC. [Acute cholestatic hepatitis induced by glimepiride] Gastroenterol Clin Biol 2000; 24: 1233-4. French. (61 year old man with a history of alcoholism developed cholestatic hepatitis 10 weeks after starting glimepiride [bilirubin 21.1 mg/dL, ALT 4 times ULN, Alk P 5 times ULN], resolving within 8 weeks of stopping). 11173739
Caksen H, Kendirci M, Tutus A, Uzüm K, Kurtoglu S. Gliclazide-induced hepatitis, hemiplegia and dysphasia in a suicide attempt. J Pediatr Endocrinol Metab 2001; 14: 1157-9. (14 year old girl developed liver injury after an overdose of gliclazide [15 tablets] and severe tonic-clonic seizures [bilirubin 4.6 mg/dL, ALT 102 U/L, Alk P 63 U/L, glucose 15 mg/dL], liver test abnormalities resolving within 3 weeks, but she was left with residual brain damage and hemoplegia). 11592575
Chitturi S, Le V, K ench J, Loh C, George J. Gliclazide-induced acute hepatitis with hypersensitivity features. Dig Dis Sci 2002; 47: 1107-10. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/12018908) (42 year old woman developed rash 4 weeks after starting gliclazide and metformin followed by jaundice at 6 weeks [bilirubin 2.9 mg/dL, ALT 1605 U/L, Alk P 158 U/L], which did not improve until gliclazide was stopped and then resolved within 6 weeks and did not recur upon reintroduction of metformin: Case 2).
Chitturi S, George J. Hepatotoxicity of commonly used drugs: nonsteroidal anti-inflammatory drugs, antihypertensives, antidiabetic agents, anticonvulsants, lipid-lowering agents, psychotropic drugs. Semin Liver Dis 2002; 22: 169-83. (Review of hepatotoxicity of antidiabetic agents, mentions that all of the sulfonylureas have been implicated in liver toxicity; that fever, rash and eosinophilia may be present suggesting an immunoallergic cause). 12016548
Chan KA, Truman A, Gurwitz JH, Hurley JS, Martinson B, Platt R, Everhart JE, et al. A cohort study of the incidence of serious acute liver injury in diabetic patients treated with hypoglycemic agents. Arch Intern Med 2003; 163: 728-34. (Industry supported retrospective cohort study of 5 health maintenance organizations databases found low rates of severe liver injury [0.06-0.10/1000 person years] with all oral antidiabetic medications: sulfonylureas, metformin and troglitazone). 12639207
Ilario MJ, Turyan HV, Axiotis CA. Glipizide treatment with short-term alcohol abuse resulting in subfulminant hepatic failure. Virchows Arch 2003; 443: 104-5. (50 year old with a history of alcohol abuse developed severe hepatitis 19 weeks after starting glipizide [bilirubin 10.2 mg/dL, ALT 2662 U/L, Alk P 232 U/L], glipizide was continued and patient developed acute liver failure and died several weeks later). 12719973
Heurgué A, Bernard-Chabert B, Higuero T, Lukas-Croisier C, Caron J, Cadiot G, Thiéfin G. [Glimepiride-induced acute cholestatic hepatitis] Ann Endocrinol(Paris) 2004; 65: 174-5. French. (54 year old man developed jaundice 2 weeks after starting glimepiride [bilirubin 16.8 mg/dL, ALT 12 times ULN, Alk P 7 times ULN], resolving within 2 months of stopping). 15247878
Chounta A, Zouridakis S, Ellinas C, Tsiodras S, Zoumpouli C, Kopanakis S, Giamarellou Hl. Cholestatic liver injury after glimepiride therapy. J Hepatol 2005; 42: 944-6. (65 year old man developed jaundice 2 weeks after starting glimepiride [bilirubin 6.9 mg/dL, ALT 141 U/L, Alk P 403 U/L], with positive rechallenge, delaying recovery to ~3 months). 15885370
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; 103 cases identified as highly probable, probable or possible, but none were attibuted to sulfonylureas). 16165719
Spiller HA, Sawyer TS. Toxicology of oral antidiabetic medications. Am J Health Syst Pharm 2006; 63: 929-38. (Review on safety of oral antidiabetic medications focusing upon hypoglycemia and overdose; little information on hepatotoxicity). 16675650
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Among 126 cases of acute liver injury from medications in a population based survey, glyburide accounted for 8 cases, relative risk of 6.1 and had an estimated incidence rate of 3.3/100,000 person years of exposure). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, one case was attributed to glipizide and one to Glucovance [metformin and glyburide]). 18955056
Tolman KG, Freston JW, Kupfer S, Perez A. Liver safety in patients with type 2 diabetes treated with pioglitazone: results from a 3-year, randomized, comparator-controlled study in the US. Drug Saf 2009; 32: 787-800. (Observational cohort study of 2097 patients with diabetes randomized to received either glyburide or pioglitazone and followed for 3 years; adverse hepatic events [ALT >3 times ULN] occurred in 0.38% of the glyburide group, but in none of the pioglitazone group). 19670918
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, of which 4 were due to troglitazone, but none to other antidiabetic medications). 20949552
Drugs for type 2 diabetes. Treat Guidel Med Lett 2011; 9 (108): 47-54. (Concise review of the role of current antidiabetic medications in management of type 2 diabetes). 21778966
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced lLiver injury in the General population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were due to sulfonylureas or other antidiabetic medications). 23419359
Ridderstråle M, Andersen KR, Zeller C, Kim G, Woerle HJ, Broedl UC; EMPA-REG H2H-SU trial investigators. Comparison of empagliflozin and glimepiride as add-on to metformin in patients with type 2 diabetes: a 104-week randomised, active-controlled, double-blind, phase 3 trial. Lancet Diabetes Endocrinol 2014; 2: 691-700. (1549 patients with diabetes inadequately controlled on metformin, were randomly assigned to be treated with the addition of empagliflozin or glimepiride for 2 years; improvements in HbA1c and adverse events were both similar in both groups; reasons for discontinuation of glimepiride in 34 patients included one case of hepatitis and one of jaundice with no further details; no mention of change in ALT levels). 24948511
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to a sulfonylurea or other antidiabetic medications). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 [0.5%] were attributed to antidiabetic medications include 2 to metformin, 1 sitagliptin and 1 glyburide [transient rise of ALT to a peak of 629 U/L without change in bilirubin, 3 months after starting glyburide and shortly after receiving doxycycline]). 25754159
Feng W, Gao C, Bi Y, Wu M, Li P, Shen S, Chen W, et al. Randomized trial comparing the effects of gliclazide, liraglutide, and metformin on diabetes with non-alcoholic fatty liver disease. J Diabetes 2017; 9: 800-9. (Among 93 patients with type 2 diabetes treated with gliclazide, liraglutide or metformin for 24 weeks, fasting blood glucose, HgA1c and ALT levels decreased in all 3 groups, but weight loss of decrease in intrahepatic fat [measured by ultrasound] decreased more with liraglutide and metformin; no mention of ALT increases or hepatotoxicity). 28332301
Campos MG, Machado J, Costa ML, Lino S, Correia F, Maltez F. Case report: Severe hematological, muscle and liver toxicity caused by drugs and artichoke infusion interaction in an elderly polymedicated patient. Curr Drug Saf 2017 Sep 12. [Epub ahead of print]. (Adult male developed muscle pains and ALT elevations after a 1.5 liter infusion of artichoke juice and while taking medications for diabetes [including gliclazide] and hypertension [enalopril and diuretics] which the authors attributed to herb-drug interactions and involvement of CYP 3A4 and 2C9). 28901251
Drugs for type 2 diabetes. Med Lett Drugs Ther 2017; 59 (1512): 9-18. (Concise review of the role of current antidiabetic medications for type 2 diabetes mentions that the sulfonylureas [glimepiride, glipizide, glyburide] are "reasonable" second-line agents that reduce HbA1c levels by 1% to 1.5%, and long term therapy reduces the risk of micro- and macro-vascular complications of diabetes without increasing the risk of myocardial infarction or stroke; the first generation sulfonylureas are not mentioned). 28076339

## OTHER REFERENCE LINKS

1. Recent References on Sulfonylureas: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(sulfonylureas/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/12/01%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Sulfonylureas: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=sulfonylureas)